# Setmelanotide

## OVERVIEW

### Introduction

Setmelanotide is a melanocortin 4 receptor agonist that is used for chronic weight management for adults and children with rare genetic forms obesity due to gene defects in the melanocortin pathway. Setmelanotide therapy has not been associated serum aminotransferase or bilirubin elevations or to instances of clinically apparent liver injury.

### Background

Setmelanotide (set” me lan’ oh tide) is an agonist of the melanocortin 4 (MC4) receptor used in the management of children 6 years or older and adults with obesity due to genetic abnormalities in the hypothalamic leptin-melanocortin pathway. Setmelanotide is a small peptide analogue of melanocyte stimulating hormone with preference for the melanocortin-4 receptor, which plays a role in regulation of hunger, satiety, and energy expenditure. These genetic forms of obesity are very rare and include pro-opiomelanocortin (POMC), proprotein convertase subtilisin/kexin type 1 (PCSK1), and leptin receptor (LEPR) deficiencies. These conditions generally present in infancy or childhood with extreme hyperphagia and severe obesity. In small open label clinical trials in these conditions, setmelanotide led to weight loss in most patients, which was usually accompanied by improvements in metabolic features such as lipid and fasting glucose levels. Setmelanotide was approved in the United States in 2020 as therapy for children and adults with obesity due to suspected deficiency of POMC, PCSK1, or LEPR. Indications were expanded in 2023 to include children and adults with obesity due to Bardet-Biedl syndrome. It is not effective in or indicated for typical (polygenic) obesity. Setmelanotide is available in multiple dose vials of 10 mg in 1 mL. The recommended starting dose in adults is 2 mg injected subcutaneously once daily for 2 weeks with increases (to 3 mg) or decreases (to 1 mg) in dose based upon tolerance and efficacy. For children below the age of 12 years, the starting dose is 1 mg with similar titration after 2 weeks. Common adverse events include injection site reactions, skin hyperpigmentation, nausea, vomiting, diarrhea, abdominal pain, headache, back pain, fatigue, depression, and spontaneous penile erection. Uncommon but potentially severe adverse events include hypersensitivity reactions, disturbances of sexual arousal, depression and suicidal ideation, marked skin pigmentation, and darkening of preexisting skin nevi. Solutions of setmelanotide also contain benzyl alcohol as a preservative which can cause serious and fatal adverse reactions in low birth rate infants.

### Hepatotoxicity

In the small open label clinical trials of setmelanotide for genetic forms of obesity, there were no reports of abnormalities of serum aminotransferase or bilirubin levels. One patient developed cholecystitis, but it was considered unrelated to therapy. Since its approval and clinical use, there have been no published cases of clinically apparent liver injury attributed to setmelanotide therapy, but elevations in serum aminotransferase levels during therapy have been described. Thus, setmelanotide therapy has not been linked to clinically apparent liver injury, but the total clinical experience with its use is limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Setmelanotide is an 8 amino acid cyclic peptide analogue of alpha melanocyte stimulating hormone and has preference for the MC4 receptor. Partial engagement of the MC1 receptor may account for its side effects of hyperpigmentation and skin darkening. It is metabolized in many tissues intracellularly by proteases into smaller peptides and amino acids and has no effect on hepatic microsomal enzymes.

### Outcome and Management

The product label for setmelanotide does not recommend monitoring of routine liver tests during therapy.

Drug Class: Weight Loss Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Setmelanotide – Imcivree®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Setmelanotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Setmelanotide | 920014-72-8 | C49-H68-N18-O9-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 July 2024

Abbreviations: (LEPR), leptin receptor; (PCSK1), proprotein convertase subtilisin/kexin type 1 (PCSK1); POMC, pro-opiomelanocortin; ULN, upper limit of normal range.

FDA. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213793Orig1s000MedR.pdf (FDA Integrated review of the data on setmelanotide safety and efficacy submitted in support of the application for its approval as therapy of several rare genetic forms of obesity mentions that “Overall, no trends or clinically meaningful changes were observed in clinical laboratory assessments throughout the studies.”).
Clément K, van den Akker E, Argente J, Bahm A, Chung WK, Connors H, De Waele K, et al.; Setmelanotide POMC and LEPR Phase 3 Trial Investigators. Efficacy and safety of setmelanotide, an MC4R agonist, in individuals with severe obesity due to LEPR or POMC deficiency: single-arm, open-label, multicentre, phase 3 trials. Lancet Diabetes Endocrinol. 2020;8:960-970. (Among 21 patients with obesity due to POMC deficiency [n=10] or LEPR deficiency [n=11] treated with setmelanotide injections for 12 weeks, followed by an 8 week placebo controlled withdrawal, and then a 32 week open label extension period, most patients lost weight and 80% of POMC vs 45% of LEPR subjects lost more than 10% of body weight, while adverse events included injection site reactions in 100%, hyperpigmentation in 71%, and nausea in 43%, but only one subject discontinued therapy because of an adverse event [eosinophilia], ALT and AST levels tended to improve with the weight loss, and there were no serious hepatic adverse events). 33137293
Haws R, Brady S, Davis E, Fletty K, Yuan G, Gordon G, Stewart M, Yanovski J. Effect of setmelanotide, a melanocortin-4 receptor agonist, on obesity in Bardet-Biedl syndrome. Diabetes Obes Metab. 2020;22:2133-2140. (Among 8 adolescents and adults with obesity due to Bardet-Biedl syndrome treated with setmelanotide, weight loss averaged 9% at 3 months and 16% at 12 months, while side effects included injection site reactions, hyperpigmentation, nausea, and vomiting and there were no discontinuations for adverse events; no mention of ALT or hepatotoxicity). 32627316
Markham A. Setmelanotide: first approval. Drugs. 2021;81:397-403. (Review of the chemical structure, mechanism of action, history of development, pharmacology, clinical efficacy, and safety of setmelanotide shortly after its approval as therapy of genetic forms of obesity in the US, discusses the frequency of common side effects, but does not mention ALT elevations or hepatotoxicity). 33638809
Setmelanotide (Imcivree) for rare genetic forms of obesity. Med Lett Drugs Ther. 2021;63(1629):e3-e4. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of setmelanotide shortly after its approval for use in the US, discusses common adverse events; no mention of ALT elevations or hepatotoxicity). 34544109
Haqq AM, Chung WK, Dollfus H, Haws RM, Martos-Moreno GÁ, Poitou C, Yanovski JA, et al. Efficacy and safety of setmelanotide, a melanocortin-4 receptor agonist, in patients with Bardet-Biedl syndrome and Alström syndrome: a multicentre, randomised, double-blind, placebo-controlled, phase 3 trial with an open-label period. Lancet Diabetes Endocrinol. 2022;10:859-868. (Among 38 patients with obesity due to Bardet-Biedl or Alström syndrome treated with setmelanotide or placebo subcutaneously once daily for 14 weeks, followed by open label drug for 52 weeks, weight loss occurred with therapy but varied by age and diagnosis, while adverse events occurred in 97% and were severe in 5%, but none were liver related; no mention of ALT elevations or hepatotoxicity). 36356613
Roth CL, Scimia C, Shoemaker AH, Gottschalk M, Miller J, Yuan G, Malhotra S, et al. Setmelanotide for the treatment of acquired hypothalamic obesity: a phase 2, open-label, multicentre trial. Lancet Diabetes Endocrinol. 2024;12:380-389. (Among 18 patients with acquired hypothalamic obesity treated with setmelanotide for up to one year, the mean weight loss was 15% and adverse events included nausea in 61%, vomiting 33%, hyperpigmentation 33%, diarrhea 22%, and two subjects discontinued therapy because of elevations in serum aminotransferase levels at 4 weeks [recurring after 6 days on re-exposure] and 12 months, specific values and other details not provided). 38697184

## OTHER REFERENCE LINKS

Recent References on Setmelanotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Setmelanotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Setmelanotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Setmelanotide)